# Felbamate

## OVERVIEW

### Introduction

Felbamate is a dicarbamate derivative anticonvulsant that is typically used in combination with other antiepileptic medications for refractory partial onset or generalized seizures. Felbamate has been associated with multiple cases of aplastic anemia and acute liver failure and its use is now restricted.

### Background

Felbamate (fel bam' ate) is a dicarbamate that has unique anticonvulsant activity. Its exact mechanism of action has not been established. Felbamate was approved for use the United States in 1993, the first new anticonvulsant medication in more than a decade. Within a year of release, however, reports of aplastic anemia and severe hepatotoxicity were received and severe warnings were placed on its use. Although still available, felbamate is rarely used because of the availability of other anticonvulsants with better safety record. Felbamate is recommended only for refractory and severe epilepsy unresponsive to other agents. Felbamate is available as tablets of 400 and 600 mg and as an oral solution fo pediatric use generically and under the brand name Febatol, but only on a limited named-patient basis. The recommended initial dose in adults is 400 to 600 mg twice daily, with dose escalation based upon tolerance. Common side effects include dizziness, nausea, somnolence and fatigue. Rare but potentially severe adverse events include suicidal thoughts and behaviors, aplastic anemia and acute hepatic failure.

### Hepatotoxicity

Prospective studies suggest that chronic felbamate therapy is not accompanied by significant elevations in serum aminotransferase levels. Nevertheless, clinically apparent hepatotoxicity from felbamate is well described, although uncommon, estimated to occur in 1 in 18,500 to 25,000 exposures, often with severe outcome. The onset of injury is 1 to 6 months after starting therapy and the pattern of enzyme elevations is typically hepatocellular. More than a dozen instances of acute liver failure and death were attributed to felbamate before severe restrictions were placed upon its use. Felbamate has not been associated with anticonvulsant hypersensitivity syndrome and is a potential alternative for persons who have developed that syndrome from other anticonvulsants.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of felbamate hepatotoxicity is unknown but is likely to be due to idiosyncratic bioactivation of felbamate to a high reactive electrophilic toxic metabolite.

### Outcome and Management

A case report of acute liver failure attributed to felbamate has been published as have several summarizes of severe cases of liver injury reported to the FDA. The fatality rate is high. Chronic injury from felbamate therapy has not been reported. There is no known cross sensitivity to liver injury between felbamate and other anticonvulsants.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Felbamate – Felbatol®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Felbamate | 25451-15-4 | C11-H14-N2-O4 | Felbamate chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 29 January 2018

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999, mentions that there have been at least 14 cases of fulminant hepatic failure linked to felbamate as well as cases of aplastic anemia).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-41. (Review of anticonvulsant induced liver injury published in 2007, mentions that felbamate has been associated with hepatic failure estimated to occur in one per 26,000-34,000 exposures; among 7 cases described, 2 were in children, 6 in women and time to onset ranged from 25 to 181 days).
McNamara JO. Pharmacology of the epilepsies. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 583-608. (Textbook of pharmacology and therapeutics).
Nightingale SL. From the FDA. Recommendation to immediately withdraw patients from treatment with felbamate. JAMA 1994; 272: 995. (FDA recommendation to immediately withdraw patients from felbamate based upon 20 reports of aplastic anemia [3 fatal]; in follow up, 34 cases of aplastic anemia [13 deaths] and 23 of acute liver failure [5 deaths] were reported: ages of 2 to 28 years, onset after 14 to 257 days). 8089899
Brodie MJ, Pellock JM. Taming the brain storms: felbamate updated. Lancet 1995; 346(8980): 918-9. (Editorial summarizing the history of the release, marketing, rapid wide scale initial use, and eventual withdrawal and restriction of felbamate; mentions 32 cases of aplastic anemia and 19 cases of liver injury, 5 of which were fatal). 7564721
Wallace SJ. A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf 1996; 15: 378-93. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, and 1% on carbamazepine, but not with gabapentin or phenobarbital; skin rashes, Stevens- Johnson syndrome and hepatic failure reported with felbamate). 8968693
O'Neil MG, Perdun CS, Wilson MB, McGown ST, Patel S. Felbamate-associated fatal acute hepatic necrosis. Neurology 1996; 46: 1457-9. (61 year old woman developed nausea and then jaundice 3-4 weeks after starting felbamate [bilirubin 2.8 rising to 18.7 mg/dL, AST 601 U/L, GGT 987 U/L, eosinophils 12%], with subsequent liver failure leading to death; autopsy showed massive collapse. Meanwhile 36 cases reported to FDA, including 5 deaths). 8628501
Li LM, Nashef L, Moriarty J, Duncan JS, Sander JW. Felbamate as add-on therapy. Eur Neurol 1996; 36: 146-8. (Among 111 patients who had felbamate added to stable anticonvulsant regimen, nausea, headache, drowsiness and dizziness were common; no case of liver injury). 8738944
Pellock JM, Brodie MJ. Felbamate: 1997 update. Epilepsia. 1997; 38: 1261-4. (Commentary about felbamate and its association with aplastic anemia and hepatotoxicity; recommended limitation in its use). 9578519
Pellock JM. Felbamate in epilepsy therapy: evaluating the risks. Drug Saf 1999; 21: 225-39. (Review of toxicity and uses of felbamate which is “too valuable an anticonvulsant to be relegated to the therapeutic scrap heap.” Seven cases of hepatic failure that were considered “likely”, including 6 women, with latency of 1-6 months, usually with other agents; an epoxide metabolite is potentially responsible for hepatotoxicity; most felbamate is excreted unmetabolized). 10487399
Dieckhaus CM, Thompson CD, Roller SG, Macdonald TL. Mechanisms of idiosyncratic drug reactions: the case of felbamate. Chem Biol Interact 2002; 142: 99-117. (Detailed analysis of metabolism of felbamate and studies in vitro and in vivo suggesting an idiosyncratic metabolic pathway and bioactivation of felbamate to a highly reactive electrophilic metabolite, possibly atropaldehyde is responsible for its idiosyncratic toxicity). 12399158
Björnsson E. Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scan 2008; 118: 281-90. (Review of all anticonvulsants; indicates that felbamate has been associated with hepatotoxicity and cases of aplastic anemia, such that it is now rarely used). 18341684
Toledano R, Gil-Nagel A. Adverse effects of antiepileptic drugs. Semin Neurol 2008; 28: 317-27. (Review of adverse reactions to anticonvulsants, including hepatotoxicity; highlights felbamate). 18777478
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 11 due to anticonvulsants [phenytoin 8, valproate 2, carbamazepine 3], but none were attributed to felbamate). 20949552
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; 11% were attributed to anticonvulsants, but none were attributed to felbamate). 20648003
Heyman E, Levin N, Lahat E, Epstein O, Gandelman-Marton R. Efficacy and safety of felbamate in children with refractory epilepsy. Eur J Paediatr Neurol 2014; 18: 658-62. (Among 50 children with refractory epilepsy treated with felbamate for an average of one year, seizure frequency decreased by half in 26 [58%] and, while 2 patients developed abnormal liver tests, none developed hepatic failure). 24906615
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were due to anticonvulsants, but none were attributed to felbamate). 25754159
Shah YD, Singh K, Friedman D, Devinsky O, Kothare SV. Evaluating the safety and efficacy of felbamate in the context of a black box warning: A single center experience. Epilepsy Behav 2016; 56:50-3. (Among 103 patients with refractory epilepsy treated with felbamate for 1 month to 20 years, adverse events included insomnia, nausea, anorexia, weight loss, diarrhea and liver enzyme elevations above 3 times ULN in one patient, but no patient developed aplastic anemia or hepatic failure). 26828692
Vidaurre J, Gedela S, Yarosz S. Antiepileptic Drugs and Liver Disease. Pediatr Neurol 2017; 77: 23-36. (Review of hepatotoxicity of anticonvulsants and their use in patients with liver disease; felbamate is listed as an agent "of last resort" because of its potential for adverse side effects including liver toxicity). 29097018

## OTHER REFERENCE LINKS

1. Recent References on Felbamate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(felbamate+AND+phenylcarbamates/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Felbamate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=felbamate)